# Efgartigimod alfa, alfa/Hyaluronidase

## OVERVIEW

### Introduction

Efgartigimod alfa is a neonatal Fc receptor blocker that is used in the treatment of adults with generalized myasthenia gravis who test positive for anti-acetylcholine receptor antibody. Efgartigimod alfa has not been associated with elevations in serum aminotransferase levels or with cases of clinically apparent liver injury.

### Background

Efgartigimod alfa (ef” gar tig’ i mod) is a modified, recombinant human IgG1 Fc fragment that binds to the neonatal Fc receptor site on cell surface membranes and prevents immunoglobulin G (IgG) recycling, thus increasing rates of IgG degradation without affecting its production or function. Efgartigimod decreases levels of IgG in the circulation which particularly affects autoantibody levels. Efgartigimod has been evaluated as therapy of several autoimmune diseases but was initially approved only for adults with myasthenia gravis. Myasthenia gravis is a rare autoimmune neuromuscular disease which is characterized by autoantibodies to the acetylcholine receptor. These autoantibodies block acetylcholine neurotransmission and result in weakness in skeletal muscles, particularly those of the eye, face, throat, and limbs. Myasthenia gravis is typically treated with anticholinesterases which prolonged acetylcholine actions, but which are usually only partly effective. Other agents used off label include corticosteroids, azathioprine, tacrolimus, methotrexate, and rituximab. Eculizumab, a monoclonal antibody to complement factor 5, was approved for use in refractory myasthenia gravis in 2017. Efgartigimod alfa was evaluated in adults with refractory myasthenia gravis and found to lead to improvements in muscle function in a high proportion of patients. Efgartigimod alfa was granted accelerated approval for use in myasthenia gravis in the United States in 2021. Current indications are limited to adults who are positive for anti-acetylcholine antibodies (found in 80 to 90% of patients). Efgartigimod alfa is available in solution in single dose vials of 400 mg/20 mL [20 mg/mL] under the brand name Vyvgart. The recommended dose regimen is 10 mg/kg given iv over one hour once weekly for 4 weeks, with further 4-week cycles based upon efficacy and tolerance. In 2023, the combination of efgartigimod alfa with hyaluronidase, which allows for subcutaneous administration, was approved for the same indication, available in single dose vials of 1008 mg of efgartigimod alfa and 11,200 units of hyaluronidase under the brand name Vyvgart Hytrulo. The recommended regimen is one vial given sc in cycles of once weekly for 4 weeks. Common side effects of efgartigimod alfa include headaches, urinary and respiratory tract infections, myalgia, paresthesia, and hematologic adverse reactions. Uncommon but potentially serious adverse events included infusion reactions, hypersensitivity reactions and infections. The two formulations of efgartigimod alfa have similar profiles of adverse events except for types of injection site reactions.

### Hepatotoxicity

In the registration studies submitted in support of approval of efgartigimod alfa, there were no serum ALT or AST elevations above 3 times the upper limit of normal (ULN) and no patient developed serum enzyme elevations and jaundice or evidence of clinically apparent liver injury. Since its approval and more widespread use including controlled trials of both intravenous and subcutaneous forms of efgartigimod, there has been no reports of clinically apparent liver injury attributed to their use.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which efgartigimod alfa alone or in combination with hyaluronidase might cause liver injury is unknown. Efgartigimod alfa is a polypeptide and is metabolized by proteolysis into individual amino acids in cells. Efgartigimod alfa is not metabolized by the cytochrome P450 system and has not been associated with drug-drug interactions. Possible exceptions, however, might be agents that can bind to the human neonatal Fc receptor such as monoclonal antibodies and immunoglobulin products.

### Outcome and Management

Efgartigimod alfa and efgartigimod alfa/hyaluronidase have not been implicated in significant serum aminotransferase elevations or instances of acute liver injury. While minor elevations in serum enzymes may occur during therapy, these are generally transient, asymptomatic, and most likely unrelated to treatment .

Drug Class: Myasthenia Agents

Other Drugs in for Myasthenia Gravis: Eculizumab, Pyridostigmine

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Efgartigimod alfa – Vyvgart®

Efgartigimod alfa/Hyaluronidase – Vyvgart Hytrulo®

DRUG CLASS

Myasthenia Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Efgartigimod%20alfa) [E. alfa]

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Efgartigimod%20alfa/Hyaluronidase) [E. alfa/hyaluronidase]

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Efgartigimod alfa | 1821402-21-4 | C2310-H3554-N602-O692-S14 | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 02 February 2025

Abbreviations: iv, intravenous; sc, subcutaneous; ULN, upper limit of normal.

Zimmerman HJ. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert textbook on hepatotoxicity published in 1999, before the availability of efgartigimod alfa).
FDA. Integrated Review. 2021. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2022/761195Orig1s000IntegratedR.pdf (FDA website with product labels and integrated review of efficacy and safety data on efgartigimod submitted by the sponsor in support of approval in the US, mentions that in the safety database of 246 subjects, adverse events more frequent with efgartigimod vs placebo included urinary tract infections, myalgia, paresthesia, respiratory tract infections, and headache, and that no participant developed ALT or AST elevations above 3 times ULN or any elevations with bilirubin above twice normal).
Howard JF Jr, Bril V, Burns TM, Mantegazza R, Bilinska M, Szczudlik A, Beydoun S, et al.; Efgartigimod MG Study Group. Randomized phase 2 study of FcRn antagonist efgartigimod in generalized myasthenia gravis. Neurology. 2019;92:e2661-e2673. (Among 24 adults with myasthenia gravis treated with efgartigimod [10 mg/kg] or placebo given iv in 4 weekly doses, there was a rapid decrease in total IgG [-40%] and anti-acetylcholine receptor antibodies with efgartigimod treatment, and adverse event rates were 83% in both groups; no mention of ALT elevations or hepatotoxicity). 31118245
Howard JF Jr, Bril V, Vu T, Karam C, Peric S, Margania T, Murai H, et al.; ADAPT Investigator Study Group. Safety, efficacy, and tolerability of efgartigimod in patients with generalized myasthenia gravis (ADAPT): a multicentre, randomised, placebo-controlled, phase 3 trial. Lancet Neurol. 2021;20:526-536. (Among 167 adults with myasthenia gravis treated with efgartigimod [10 mg/kg] vs placebo iv in cycles of 4 weekly iv infusions, response rates were 68% vs 30% with the first cycle and adverse event rates 77% vs 84% which were serious in 5% vs 8%, and “there were no clinically meaningful changes in haematology or chemistry parameters”). 34146511
Efgartigimod alfa (Vyvgart) for myasthenia gravis. Med Lett Drugs Ther. 2022;64:62-63. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of efgartigimod alfa shortly after its approval for use in myasthenia gravis in the US, mentions common adverse events of headache, respiratory and urinary tract infections, paresthesia, myalgia, and hematologic abnormalities; no mention of ALT elevations or hepatotoxicity). 35436776
Broome CM, McDonald V, Miyakawa Y, Carpenedo M, Kuter DJ, Al-Samkari H, Bussel JB et al.; ADVANCE Investigator Study Group. Efficacy and safety of the neonatal Fc receptor inhibitor efgartigimod in adults with primary immune thrombocytopenia (ADVANCE IV): a multicentre, randomised, placebo-controlled, phase 3 trial. Lancet. 2023;402(10413):1648-1659. (Among 131 adults with primary immune thrombocytopenia treated with efgartigimod [10 mg/kg] or placebo in weekly iv infusions, clinical responses occurred in 22% vs 5% and adverse events in 93% vs 96% which were serious in 8% vs 16%; no mention of ALT elevations or hepatotoxicity). 37778358
Howard JF Jr, Bril V, Vu T, Karam C, Peric S, De Bleecker JL, Murai H, et al.; ADAPT+ Study Group. Long-term safety, tolerability, and efficacy of efgartigimod (ADAPT+): interim results from a phase 3 open-label extension study in participants with generalized myasthenia gravis. Front Neurol. 2024;14:1284444. (Among 151 adults with myasthenia gravis enrolled in a long term,, open label extension study of efgartigimod alfa given in cycles of 4 weekly iv infusions [10 mg/kg], clinical responses were maintained and adverse events were mostly mild-to-moderate, resulted in discontinuation in 8%, and fatality in 5, none of which were considered drug- or liver related; no mention of ALT elevations or hepatotoxicity). 38318236
Howard JF Jr, Vu T, Li G, Korobko D, Smilowski M, Liu L, Gistelinck F, et al.; ADAPT-SC and ADAPT-SC+ Study Groups. Subcutaneous efgartigimod PH20 in generalized myasthenia gravis: A phase 3 randomized noninferiority study (ADAPT-SC) and interim analyses of a long-term open-label extension study (ADAPT-SC+). Neurotherapeutics. 2024;21:e00378. (Among 145 adults with myasthenia gravis enrolled in an extended open label trial of efgartigimod alfa/hyaluronidase in cycles of 10 mg/kg given sc weekly for 4 weeks [average duration 569 days and up to 17 cycles], adverse events arose in 85%, most frequent symptoms being headache, COVID-19, diarrhea, urinary and respiratory tract infections, fever, nausea, hypertension, and oropharyngeal pain, and “there were no clinically relevant changes from baseline in hematology and chemistry parameters”). 39227284
Allen JA, Lin J, Basta I, Dysgaard T, Eggers C, Guptill JT, Gwathmey KG, et al.; ADHERE Study Group. Safety, tolerability, and efficacy of subcutaneous efgartigimod in patients with chronic inflammatory demyelinating polyradiculoneuropathy (ADHERE): a multicentre, randomised-withdrawal, double-blind, placebo-controlled, phase 2 trial. Lancet Neurol. 2024;23:1013-1024. (Among 221 adults with chronic inflammatory demyelinating polyradiculoneuropathy treated with efgartigimod alfa/hyaluronidase or placebo sc once weekly for 4 weeks, relapses were less frequent with efgartigimod [28% vs 56%], while adverse events arose in 64% vs 56% and severe adverse events in 5% vs 5%; no mention of ALT elevations or hepatotoxicity). 39304241

## OTHER REFERENCE LINKS

1. Recent References on Efgartigimod alfa: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Efgartigimod+alfa/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Efgartigimod alfa: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Efgartigimod%20alfa)